# Riociguat

## OVERVIEW

### Introduction

Riociguat is a stimulator of guanylate cyclase which causes relaxation of vascular smooth muscle and is used to treat severe pulmonary arterial hypertension. Riociguat has not been linked to significant serum enzyme elevations during therapy or to instances of clinically apparent acute liver injury.

### Background

Riociguat (rye" oh sig' ue at) is small molecular weight stimulator of soluble guanylate cyclase, an enzyme responsible for synthesis of cyclic guanine monophosphate (cyclic GMP), an important mediator of endothelial cell relaxation. By stimulating cyclic GMP, riociguat leads to relaxation of vascular smooth muscle cells, particularly in the pulmonary vasculature. In humans, riociguat induces pulmonary arterial vasodilation and reduces pulmonary artery pressure. In several clinical trials, prolonged therapy with riociguat has been shown to improve exercise capacity and pulmonary function in patients with severe idiopathic as well as chronic thromboembolic pulmonary arterial hypertension (PAH). Riociguat was approved for use in chronic idiopathic and thromboembolic PAH in 2013 and it is currently available in tablets of 0.5, 1.0, 1.5, 2.0 and 2.5 mg under the brand name Adempas. The recommended starting dose is 1 mg three times daily which can be increased in 0.5 mg amounts every two weeks based upon tolerance to a maximum of 2.5 mg thrice daily. Side effects are generally dose related and can include hypotension, syncope, dizziness, headache, diarrhea, gastrointestinal upset, nausea, vomiting and constipation, symptoms that are frequent with most vasodilator therapies. Rare, but potentially severe adverse reactions include pulmonary hemorrhage and fetal toxicity. Women of childbearing potential can receive riociguat only as a part of a risk evaluation and mitigation strategy (REMS) program that requires regular monitoring.

### Hepatotoxicity

In preregistration studies, riociguat was not associated with serum enzyme elevations or with episodes of clinically apparent liver injury. Since approval of riociguat, there have been no published reports of hepatotoxicity, and the product label does not mention liver injury as an adverse event.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which riociguat might cause serum aminotransferase elevations or liver injury is not known. It is metabolized by the hepatic cytochrome P450 system (predomination 3A4 and is susceptible to drug-drug interactions. The absence of significant hepatotoxicity from riociguat may related to the relatively low daily doses used (3.0 to 7.5 mg).

### Outcome and Management

The serum enzyme elevations associated with riociguat use have been rare, mild-to-moderate and self-limited in course, usually resolving despite drug continuation. Clinically apparent liver injury from riociguat has not been described. There is no information on cross sensitivity to hepatic injury among the various agents used to treat pulmonary artery hypertension.

Drug Class: Pulmonary Arterial Hypertension Agents

Other Drugs in the Subclass, Guanylate Cyclase Inhibitors: Vericiguat

Other Drugs in the Class: Ambrisentan, Bosentan, Macitentan, Selexipag; Prostacyclin Analogs, Epoprostenol, Iloprost, Treprostinil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Riociguat – Adempas®

DRUG CLASS

Pulmonary Arterial Hypertension Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Riociguat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Riociguat | 625115-55-1 | C20-H19-F-N8-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 04 June 2018

Abbreviations used: PAH, pulmonary arterial hypertension.

Zimmerman HJ. Acetaminophen toxicity. Syndromes of environmental hepatotoxicity. In, Zimmerman, HJ. Hepatotoxicity. The adverse effects of drugs and other chemicals upon the liver. 2nd edition. Philadelphia. Lippincott, 1999. pp 337-46. (Textbook of drug induced liver injury published in 1999 before the availability of riociguat).
Barnes PJ. Pharmacotherapy of pulmonary arterial hypertension. Pulmonary Pharmacology. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1059-61. (Textbook of pharmacology and therapeutics).
Ghofrani HA, Galiè N, Grimminger F, Grünig E, Humbert M, Jing ZC, Keogh AM, et al., PATENT-1 Study Group. (2013). Riociguat for the treatment of pulmonary arterial hypertension. N Engl J Med. (Among 443 patients with pulmonary arterial hypertension [PAH] treated with riociguat or placebo for 12 weeks, exercise capacity improved with riociguat and side effects included headache, dyspepsia, peripheral edema, nausea, dizziness and diarrhea, and one patient required early discontinuation of therapy because of serum enzyme elevations, but no details provided).
Ghofrani HA, D'Armini AM, Grimminger F, Hoeper MM, Jansa P, Kim NH, Mayer E, et al., CHEST-1 Study Group. (2013). Riociguat for the treatment of chronic thromboembolic pulmonary hypertension. N Engl J Med. (Among 261 patients with chronic thromboembolic PAH treated with riociguat or placebo for 16 weeks, exercise capacity improved with riociguat and side effects included headache, dizziness, dyspepsia, sinusitis, nausea, vomiting, diarrhea and hypotension; there were no liver related serious adverse events).
(2014). Riociguat (Adempas) for pulmonary hypertension. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of riociguat shortly after its approval for use in the US mentions the common side effects and teratogenicity, but makes no mention of ALT elevations or hepatotoxicity).
Rubin LJ, Galiè N, Grimminger F, Grünig E, Humbert M, Jing ZC, Keogh A, et al. (2015). Riociguat for the treatment of pulmonary arterial hypertension: a long-term extension study (PATENT-2). Eur Respir J. (Among 396 patients with PAH who were treated with riociguat or placebo in a randomized controlled trial and were then continued or started riociguat, improvements in exercise capacity persisted for the year of therapy and side effects included hypotension, syncope, dizziness and headache; no mention of ALT elevations or hepatotoxicity).
Hill NS, Badesch D, Benza RL, D'Eletto TA, Farber HW, Gomberg-Maitland M, Hassoun PM, Preston I. (2015). Perspectives on oral pulmonary hypertension therapies recently approved by the U.S. Food and Drug Administration. Ann Am Thorac Soc. (Review of recently approved drugs for PAH including macitentan, riociguat and oral treprostinil mentions that riociguat can cause significant hypotension and is embryotoxic; no mention of ALT elevations or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one was attributed to bosentan, but none to riociguat or other agents used primarily to treat pulmonary artery hypertension).
Ghofrani HA, Grimminger F, Grünig E, Huang Y, Jansa P, Jing ZC, Kilpatrick D, et al. (2016). Predictors of long-term outcomes in patients treated with riociguat for pulmonary arterial hypertension: data from the PATENT-2 open-label, randomised, long-term extension trial. Lancet Respir Med. (Among 396 patients with PAH who had participated in a placebo controlled trial and then were treated with open label riociguat, exercise capacity was maintained for the duration of therapy [up to 2 years] and no new side effects were evident; no mention of serum ALT elevations or clinically apparent liver injury).
Simonneau G, D'Armini AM, Ghofrani HA, Grimminger F, Jansa P, Kim NH, Mayer E, et al. (2016). Predictors of long-term outcomes in patients treated with riociguat for chronic thromboembolic pulmonary hypertension: data from the CHEST-2 open-label, randomised, long-term extension trial. Lancet Respir Med. (Among 237 patients with chronic thromboembolic PAH who had participated in a placebo controlled trial and then were treated with open label riociguat, exercise capacity was maintained for the duration of therapy [up to 2 years] and no new side effects were evident; no mention of serum ALT elevations or clinically apparent liver injury).
Humbert M, Coghlan JG, Ghofrani HA, Grimminger F, He JG, Riemekasten G, Vizza CD, et al. (2017). Riociguat for the treatment of pulmonary arterial hypertension associated with connective tissue disease: results from PATENT-1 and PATENT-2. Ann Rheum Dis. (Analysis of 111 patients with connective tissue disease associated PAH from previous controlled trials of riociguat [Ghofrani et al 2013 and 2016] found similar rates of improvements and side effects as found in the entire treated population; no mention of ALT elevations or hepatotoxicity).
Halank M, Hoeper MM, Ghofrani HA, Meyer FJ, Stähler G, Behr J, Ewert R, et al. (2017). Riociguat for pulmonary arterial hypertension and chronic thromboembolic pulmonary ypertension: Results from aphase II long-term extension study. Respir Med. (Among 68 patients with PAH treated with riociguat in a long term extension study following a controlled trial [Ghofrani 2013], clinical improvements were maintained and no new adverse events were found; no mention of ALT levels or hepatotoxicity).
McLaughlin VV, Jansa P, Nielsen-Kudsk JE, Halank M, Simonneau G, Grünig E, Ulrich S, et al. (2017). Riociguat in patients with chronic thromboembolic pulmonary hypertension: results from an early access study. BMC Pulm Med. (Among 262 patients with recurrent or persistent chronic thromboembolic PAH treated with riociguat in an open access study for an average of 1 year, common adverse events included dizziness, headache, syncope, peripheral edema and gastrointestinal symptoms; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Riociguat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Riociguat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Riociguat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Riociguat)